# Fibrates

## OVERVIEW

Fibrates are fibric acid derivative agents and are used to lower plasma lipids and particularly triglyceride levels. Chronic therapy with fibrates has been associated with transient mild elevations in serum aminotransferase levels and with rare instances of acute liver injury, which can be severe and evolve into chronic hepatitis, with progressive fibrosis and cirrhosis.

Fibrates are derivatives of fibric acid. Therapy with fibrates in humans leads to a lowering of serum very low density lipoprotein (VLDL) levels leading to decreases in triglyceride and cholesterol levels. Several fibrates have also been found to decrease low density lipoprotein (LDL) and increase high density lipoprotein (HDL) levels, but their effects are, in general, less than what can be achieved with the statins. The fibrates are currently used largely in patients with hypertriglyceridemia and are used in combination with statins to treat hypercholesterolemia.

The mechanism by which the fibrates lower lipid levels is unknown, but they may act through interactions with the hepatic peroxisome proliferator activated receptors (PPARs) which regulate gene transcription of enzymes involved in lipid synthesis and secretion. The fibrates bind specifically to a PPAR alpha isozyme, which is found largely in the liver and which regulates fatty acid oxidation, increasing lipoprotein lipase levels which, in turn, enhances clearance of triglyceride rich lipoproteins.

Three fibrates have been used in the United States: Gemfibrozil (Lopid: 1981), Fenofibrate (Lofibra, Tricor, Antara, Lipofen, Triglide: 1993), and Clofibrate (Abitrate, Atromid-S). Clofibrate has been withdrawn from use, largely because of concerns regarding increased risk of cancer and studies showing that, despite its cholesterol lowering activity, clofibrate therapy is not associated with a decrease in cardiovascular mortality. All three of the fibrates are associated with mild-to-moderate serum aminotransferase elevations during therapy that are typically transient, asymptomatic and may resolve even without discontinuation. All three agents have also been linked to cases of clinically apparent acute liver injury, fenofibrate most frequently and convincingly. The frequency and pattern of hepatic injury varies with the different fibrates and they do not appear to share a common pathway or class effect in causing liver injury. For these reasons each fibrate is discussed separately. The acute liver injury from the fibrates can be severe and prolonged and, unlike most forms of drug induced liver injury, can lead to chronic liver disease and cirrhosis.

Drug Class: Antilipemic Agents

Drugs in the Subclass, Fibrates: Clofibrate, Fenofibrate, Gemfibrozil

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Clofibrate | 637-07-0 | C12-H15-Cl-O3 | Image of Chemical Structure
Fenofibrate | 49562-28-9 | C20-H21-Cl-O4 | Image of Chemical Structure
Gemfibrozil | 25812-30-0 | C15-H22-O3 | Image of Chemical Structure